# DILI Information Resources

## Contents

- Featured Resources
- Monitoring Systems
- Bibliographic
- Registries and Research
- Factual
- Select Review Articles
- Imaging
- Promotional Brochure

## < Featured Resources >

Hoofnagle JH, Björnsson ES. (2019). Drug-induced liver injury – types and phenotypes. N Engl J Med.
Devarbhavi H, Aithal G, Treeprasertsuk S, Takikawa H, Mao Y, Shasthry SM, Hamid S, Tan SS, et al., Asia Pacific Association of Study of Liver. (2021). Drug-induced liver injury: Asia Pacific Association of Study of Liver consensus guidelines. Hepatol Int.

## Bibliographic

- PubMed – Bibliographic citations and full text from the world's biomedical literature (https://pubmed.ncbi.nlm.nih.gov/)National Center for Biotechnology Information, National Library of Medicine
- TOXLINE – Toxicology focused citations and full text from the world's biomedical literature (https://pubmed.ncbi.nlm.nih.gov/?term=tox%20%5Bsubset%5D%20AND%20)National Center for Biotechnology Information, National Library of Medicine

## Factual

- FDA DILI Conference – See Meetings and News in the LiverTox SidebarThe US Food and Drug Administration, Center for Drug Evaluation and Research (FDA/CDER) sponsors an annual Drug-Induced Liver Injury Conference.
- ChemIDplus Advanced – Chemical substance information, plus substructure and similarity search capability (https://chem.nlm.nih.gov/chemidplus/)National Library of Medicine, NIH
- DailyMed – Medication labeling (package inserts) and related product information (https://dailymed.nlm.nih.gov/dailymed/index.cfm) National Library of Medicine, NIH
- NCCIH Herbs at a Glance – Fact sheets about specific herbs or botanicals (https://www.nccih.nih.gov/health/herbsataglance)National Center for Complementary and Integrative Health, NIH
- Natural Medicines Comprehensive Database – Evidence-based information on natural medicines (https://naturalmedicines.therapeuticresearch.com/)Therapeutic Research Center, Natural Medicines
- ODS Dietary Supplement Fact Sheets (https://ods.od.nih.gov/factsheets/list-all/)Office of Dietary Supplements, NIH

## Imaging

- MedPics – Clinical, hematology, histology and pathology image and text database system (https://medpics.ucsd.edu/index.cfm)University of California San Diego, School of Medicine
- MedPix – Arrayed radiographic image and text database, including patient profiles (https://medpix.nlm.nih.gov/home) Lister Hill National Center for Biomedical Communications, National Library of Medicine, NIH

## Monitoring Systems

- FAERS/FDA Adverse Event Reporting System – Postmarketing adverse drug event reporting (https://www.fda.gov/drugs/questions-and-answers-fdas-adverse-event-reporting-system-faers/fda-adverse-event-reporting-system-faers-public-dashboard) Center for Drug Evaluation and Research, Food and Drug Administration
- MedWatch – FDA Postmarketing product safety reporting program (https://www.fda.gov/safety/medwatch-fda-safety-information-and-adverse-event-reporting-program)Center for Drug Evaluation and Research, Food and Drug Administration

## Registries and Research

- ALF/Acute Liver Failure Study Group – Registry for all forms of liver failure (https://www.utsouthwestern.edu/labs/acute-liver/)University of Texas Southwestern Medical Center at Dallas
- ClinicalTrials – Registry of federally and privately supported clinical research (https://www.clinicaltrials.gov/)National Library of Medicine, NIH
- DILIN/Drug-Induced Liver Injury Network – Registry, analysis of cases of drug-induced liver injury (https://dilin.org/) National Institute of Diabetes and Digestive and Kidney Diseases; Duke Clinical Research Institute; Consortium of nine clinical centers
- EDKB/Endocrine Disruptor Knowledge Base – For computational predictive toxicology models (https://www.fda.gov/science-research/bioinformatics-tools/endocrine-disruptor-knowledge-base)National Center for Toxicological Research, Food and Drug Administration
- LTKB/Liver Toxicity Knowledge Base (https://www.fda.gov/science-research/bioinformatics-tools/liver-toxicity-knowledge-base-ltkb)– Resources for understanding drug-induced liver injury
- LTKB/Liver Toxicity Knowledge Base Benchmark Dataset (https://www.fda.gov/science-research/liver-toxicity-knowledge-base-ltkb/ltkb-benchmark-dataset)
- LTKB/Liver Toxicity Knowledge Base Publications (https://www.fda.gov/science-research/liver-toxicity-knowledge-base-ltkb/liver-toxicity-knowledge-base-publications)National Center for Toxicological Research, Food and Drug Administration
- PALF/Pediatric Acute Liver Failure Study Group – Registry for all forms of pediatric liver failure (https://www.chop.edu/pages/pediatric-acute-liver-failure-study-group)University of Pittsburgh

## Select Review Articles [Recent 4 Years]

1 Hey-Hadavi J, Seekins D, Palmer M, Coffey D, Caminis J, Abdullaev S, Patwardhan M, et al. (2021). Overview of causality assessment for drug-induced liver injury (DILI) in clinical trials. Drug Saf.
2 Devarbhavi H, Aithal G, Treeprasertsuk S, Takikawa H, Mao Y, Shasthry SM, Hamid S, Tan SS, et al., Asia Pacific Association of Study of Liver. (2021). Drug-induced liver injury: Asia Pacific Association of Study of Liver consensus guidelines. Hepatol Int.
3 Liu A, Walter M, Wright P, Bartosik A, Dolciami D, Elbasir A, Yang H, Bender A. (2021). Prediction and mechanistic analysis of drug-induced liver injury (DILI) based on chemical structure. Biol Direct.
4 Takemura A, Ito K. (2020). Nihon Yakurigaku Zasshi.
5 Apel K, Pütz K, Tolkach Y, Canbay A, Drebber U. (2020). Drug-induced liver injury – Stellenwert der Pathologie. Pathologe.
6 Low EXS, Zheng Q, Chan E, Lim SG. (2020). Drug induced liver injury: East versus West – a systematic review and meta-analysis. Clin Mol Hepatol.
7 Gasmi B, Kleiner DE. (2020). Liver histology: diagnostic and prognostic features. Clin Liver Dis.
8 Watkins PB. (2020). Quantitative systems toxicology approaches to understand and predict drug-induced liver injury. Clin Liver Dis.
9 Thakkar S, Li T, Liu Z, Wu L, Roberts R, Tong W. (2020). Drug-induced liver injury severity and toxicity (DILIst): binary classification of 1279 drugs by human hepatotoxicity. Drug Discov Today.
10 Andrade RJ, Robles-Díaz M. (2020). Diagnostic and prognostic assessment of suspected drug-induced liver injury in clinical practice. Liver Int.
11 Andrade RJ, Chalasani N, Björnsson ES, Suzuki A, Kullak-Ublick GA, Watkins PB, Devarbhavi H, et al. (2019). Drug-induced liver injury. Nat Rev Dis Primers.
12 Hoofnagle JH, Björnsson ES. (2019). Drug-induced liver injury – types and phenotypes. N Engl J Med.
13 Uetrecht J. (2019). Mechanisms of idiosyncratic drug-induced liver injury. Adv Pharmacol.
14 Sarin SK, Choudhury A, Sharma MK, Maiwall R, Al Mahtab M, Rahman S, Saigal S, et al. (2019). APASL ACLF Research Consortium (AARC) for APASL ACLF working Party. Acute-on-chronic liver failure: consensus recommendations of the Asian Pacific association for the study of the liver (APASL): an update. Hepatol Int.
15 He S, Zhang C, Zhou P, Zhang X, Ye T, Wang R, Sun G, Sun X. (2019). Herb-induced liver injury: phylogenetic relationship, structure-toxicity relationship, and herb-ingredient network analysis. Int J Mol Sci.
16 McGill MR, Jaeschke H. (2019). Biomarkers of drug-induced liver injury. Adv Pharmacol.
17 Real M, Barnhill MS, Higley C, Rosenberg J, Lewis JH. (2019). Drug-induced liver injury: highlights of the recent literature. Drug Saf.
18 García-Cortés M, Ortega-Alonso A, Lucena MI, Andrade RJ, Spanish Group for the Study of Drug-Induced Liver Disease. (2018). (Grupo de Estudio para las Hepatopatías Asociadas a Medicamentos GEHAM). Drug-induced liver injury: a safety review. Expert Opin Drug Saf.
19 Roytman MM, Poerzgen P, Navarro V. (2018). Botanicals and Hepatotoxicity. Clin Pharmacol Ther.
20 Ortega-Alonso A, Andrade RJ. (2018). Chronic liver injury induced by drugs and toxins. J Dig Dis.
21 Kleiner DE. (2018). Recent advances in the histopathology of drug-induced liver injury. Surg Pathol Clin.
22 Thakkar S, Chen M, Fang H, Liu Z, Roberts R, Tong W. (2018). The Liver Toxicity Knowledge Base (LKTB) and drug-induced liver injury (DILI) classification for assessment of human liver injury. Expert Rev Gastroenterol Hepatol.
23 Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol.
24 Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology.

## LiverTox Promotional Handout

- Users of LiverTox are encouraged to reproduce the LiverTox Handout for distribution at relevant professional/scientific meetings.